# Yerba Mate

## OVERVIEW

### Introduction

Yerba mate is a caffeinated herbal drink popular in South America that is used much like coffee or tea as a refreshing and stimulating beverage. It has recently become popular in the United States and Europe as a drink as well as a component of multiingredient dietary supplements. Yerba mate is generally regarded as safe and despite broad scale use has been recently linked to rare instances of clinically apparent liver injury.

### Background

Yerba mate is prepared from the leaves and small stems of the evergreen tree, Ilex paraguariensis, that is native to Paraguay, Uruguay, and parts of Brazil and Argentina. Yerba mate as a beverage was first used by the native Guarani people and was later popularized by missionary Jesuits in the area which led to a more widespread use. Yerba mate is now a popular drink in South America prepared as tea or as a cold soft drink sold in bottles and cans. More recently, it has become a popular herbal drink in the United States and in Europe as well as a component in multiingredient herbal products. In preparation of Yerba mate, the leaves are typically baked, dried, and ground into a powder that may be flavored with citrus fruit or other flavoring substances and sold as a powder for preparing tea or made into a drinkable form and sold in bottles or cans. Yerba mate has multiple methylxanthines including caffeine, theobromine, and theophylline, and drinks made from the herb typically have concentrations of caffeine similar to those in tea and coffee. In addition, Yerba mate has polyphenols that are believed to be antioxidants as well as flavonoids (such as rutin and quercetin), anthocyanins, triterpene saponins, phytosterols, amino acids, minerals, and vitamins. Yerba mate is claimed to increase vitality and mental concentration and to decrease hunger. It is also purported to improve serum lipids, cause weight loss, decrease inflammation, benefit cardiovascular health, and even to prevent liver injury. The levels of caffeine may explain some of the effects found with Yerba mate, but the health promoting properties are usually attributed to its other components. The general health claims made for Yerba mate, however, have not been shown in rigorously controlled and adequately powered clinical trials, and it is not approved in the United States as therapy for any disease or condition. Nevertheless, Yerba mate is widely available as a powdered extract and as canned or bottled liquid drinks. Yerba mate extracts also are found in multiingredient dietary supplements, typically advertised as helpful for weight loss and for metabolic health, well-being, and longevity. The typical dose ranges widely and is difficult to estimate but is probably in the range of 1 to 3 grams daily. Side effects are uncommon but with excessive intake, caffeine related adverse events such as palpitations, nervousness, headache, and insomnia may arise. Epidemiologic studies suggest that long term use of Yerba mate may increase the risk of head and neck cancers.

### Hepatotoxicity

In small, short term clinical studies of different preparations and concentrations of Yerba mate, adverse side effects were usually described as absent or minimal with no mention of hepatotoxicity. Typical tests for liver and kidney injury or dysfunction were unchanged and normal. Despite these findings and its long history of use, Yerba mate has been implicated in causing liver injury in a few published cases. Details of the liver injury have not been well defined. In a recent case report, a 21 year old American man developed jaundice and itching after 4 months of drinking Yerba mate daily while visiting Argentina. The injury was strikingly hepatocellular with ALT and AST values more than 50 times the upper limit of normal (ULN), but alkaline phosphatase less than twice ULN, despite a bilirubin above 30 mg/dL. All known causes of acute hepatitis were excluded. Immune allergic symptoms (fever and rash) were not present and liver biopsy showed an acute hepatitis with cholestasis. The patient recovered without treatment within 2 months of stopping the herbal drink. While unusual, the case report was reasonably convincing as no other cause was evident, and improvement followed stopping the herbal drink. Thus, liver injury from Yerba mate might be considered possible but is exceedingly rare.

Likelihood score: D (possible but rare cause of clinically apparent liver injury).

### Mechanism of Injury

Yerba mate has multiple constituents, and the chemical compound responsible for liver injury is not known. The clinical features of the single case of Yerba mate associated liver injury suggest that it was immunologically mediated. The injury resembled that of green tea or turmeric associated liver injury which are believed to be caused by polyphenols.

### Outcome and Management

The single carefully described case of liver injury from Yerba mate resolved spontaneously and completely once the herbal drink was discontinued. There is no information on cross sensitivity to liver injury with other similar herbal drinks.

Drug Class: Herbal and Dietary Supplements

Other names: Paraguay Tea, Mate Tea, Erva Mate

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ilex paraguariensis – Generic

DRUG CLASS

Herbal and Dietary Supplements

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/828.html)

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Caffeine | 58-08-2 | C8-H10-N4-O2
Caffeic Acid | 501-16-6 | C9-H8-O4
Chlorogenic Acid | 202650-88-2 | C16-H18-O9

## ANNOTATED BIBLIOGRAPHY

References updated: 10 November 2024

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not Yerba mate).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of HDS published in 2007; no mention of Yerba mate).
McGee J, Patrick RS, Wood CB, Blumgart LH. A case of veno-occlusive disease of the liver in Britain associated with herbal tea consumption. J Clin Pathol. 1976;29:788-94. (26 year old woman developed abdominal pain and fatigue having used large amounts of herbal teas [including Yerba mate: “Paraguay tea”] for years and presented with ascites [bilirubin 0.8 mg/dL, ALT 28 U/L, Alk P 303 U/L, prothrombin time 19 sec], biopsy demonstrating veno-occlusive disease [sinusoid obstruction syndrome (SOS)] and subsequently dying of multiorgan failure; testing of the tea revealed contamination with pyrrolizidine alkaloids known to cause SOS). 977780
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list Yerba mate among products associated with 5 or more reports). 19650152
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not mention or list Yerba mate or Ilex paraguariensis). 22928722
Harrold JA, Hughes GM, O'Shiel K, Quinn E, Boyland EJ, Williams NJ, Halford JC. Acute effects of a herb extract formulation and inulin fibre on appetite, energy intake and food choice. Appetite. 2013;62:84-90. (Among 58 adult overweight women given either 3 tablets of a combination of Yerba mate, guarana, and damiana [YGD], or a soluble fermentable fiber [SFF], or placebo before meals, total food intake was less, but hunger was unchanged with YGD tablets and SFF, and was greatest with the combination, while no adverse events occurred; serum ALT and AST were not measured). 23207186
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to Yerba mate). 25043597
Kim SY, Oh MR, Kim MG, Chae HJ, Chae SW. Anti-obesity effects of Yerba mate (Ilex paraguariensis): a randomized, double-blind, placebo-controlled clinical trial. BMC Complement Altern Med. 2015;15:338. (Among 30 overweight or obese adults treated with Yerba mate [3 gm daily] or placebo for 12 weeks, there were no differences in changes in body weight, dietary intake, or serum lipids between the two groups, and there were no adverse side effects, routine liver tests did not change and remained normal). 26408319
Alkhatib A, Atcheson R. Yerba Maté (Ilex paraguariensis) metabolic, satiety, and mood state effects at rest and during prolonged exercise. Nutrients. 2017;9:882. (Among 12 healthy, active adult women ingesting Yerba mate [2 gm] or placebo shortly before a 30 minute cycling exercise in a repeated measures design, fatty acid oxidation and measures of hunger and mental concentration were improved with Yerba mate ingestion; no mention of adverse events). 28809814
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products lists one case exposed to 12 herbal products including Yerba mate). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of Yerba mate). 29307848
Poswal FS, Russell G, Mackonochie M, MacLennan E, Adukwu EC, Rolfe V. Herbal teas and their health benefits: a scoping review. Plant Foods Hum Nutr. 2019;74:266-276. (Among 21 human studies on the health benefits of herbal teas, only 7 discussed adverse events and only one dealt with Yerba mate; no mention of hepatoxicity of herbal teas). 31243622
Rodriguez EA, Teixeira Yokoda R, Payton DE, Pai R, Byrne TJ. Acute hepatitis secondary to the use of Ilex paraguariensis (mate tea): a case report and review of literature. Case Reports Hepatol. 2019;2019:8459205. (21 year old American developed jaundice after a 4 month church-mission visit in Argentina during which he drank Yerba mate daily [bilirubin 32.9 mg/dL, ALT 2685 U/L, AST 1842 U/L, and Alk P 129 U/L], a liver biopsy showing an acute hepatitis with cholestasis while viral and autoimmune tests were all negative, resolving spontaneously without therapy over the next 2 months after stopping the herbal beverage). 31737383
Lutomski P, Goździewska M, Florek-Łuszczki M. Health properties of Yerba Mate. Ann Agric Environ Med. 2020;27:310-313. (Brief review of the health benefits of Yerba mate including a role in weight loss, prevention of infections, improving serum lipids and cardiovascular health and the stimulatory effects of its caffeine; mentions the possible increased risk for head and neck cancer of long term use, but no mention of liver injury). 32588612
Gawron-Gzella A, Chanaj-Kaczmarek J, Cielecka-Piontek J. Yerba mate—a long but current history. Nutrients. 2021;13:3706. (Review of the preparation of Yerba mate, its composition, biological activities, clinical effects, and toxicity, mentions the increased risk for head and neck cancer, which has been linked to use to heated Yerba mate). 34835962
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; mentions that erva mate, another name for Yerba mate that was implicated in 3 cases, details and references not provided). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while Yerba mate was not mentioned). 33434654

## OTHER REFERENCE LINKS

1. Recent References on Yerba mate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Yerba+mate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Yerba mate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Yerba%20mate)